# Etodolac

## OVERVIEW

### Introduction

Etodolac is a nonsteroidal antiinflammatory drug (NSAID) that is available by prescription only and is used long term for therapy of chronic arthritis and short term for acute pain. Etodolac has been linked to rare instances of clinically apparent drug induced liver disease.

### Background

Etodolac (e toe' doe lak) belongs to the acetic acid derivative class of NSAIDs similar to diclofenac, sulindac, ketorolac, and indomethacin. Like other NSAIDs, etodolac is a potent cyclo-oxygenase (Cox-1 and -2) inhibitor which blocks the formation of prostaglandins that are important in pain and inflammatory pathways. It has analgesic as well as antipyretic and antiinflammatory activity. Etodolac was approved in the United States in 1991 and current indications include treatment of osteoarthritis and rheumatoid arthritis and for short term treatment of acute pain. Etodolac is available by prescription only and currently more than 250,000 prescriptions are filled yearly. Etodolac is available as capsules in doses of 200, 300, 400 and 500 mg generically and under the trade name Lodine. Extended release formulations of 400, 500 and 600 mg are also available for once or twice daily dosing. The recommended dose is 400 to 1200 mg in 2 to 4 divided doses daily, based upon response and tolerance. Like other NSAIDs, etodolac is generally well tolerated, but side effects can include headache, dizziness, somnolence, dyspepsia, nausea, abdominal discomfort, heartburn, diarrhea, peripheral edema, pruritus, infertility, fetal toxicity, and hypersensitivity reactions. Rare but potentially serious adverse events from NSAIDs such as etodolac include gastrointestinal ulceration, bleeding, and perforation, an increased risk for serious cardiovascular disease including myocardial infarction and stroke, renal dysfunction, exacerbation of asthma, and acute hypersensitivity reactions including anaphylaxis, exfoliative dermatitis, and Stevens Johnson syndrome.

### Hepatotoxicity

Prospective studies show that 1% to 2% of patients taking etodolac experience at least transient serum aminotransferase elevations. These may resolve even with drug continuation. Marked aminotransferase elevations (greater than 3 fold elevated) occur in less than 1% of patients.

Clinically apparent liver injury with jaundice from etodolac is rare but several convincing cases have been published. The latency to onset ranged a few days to several months and the pattern of enzyme elevations has been described as cholestatic, hepatocellular, and mixed. Perhaps the most typical presentation is with jaundice 3 to 6 months after starting etodolac with a mixed or hepatocellular pattern of injury, and fairly rapid recovery on stopping. Immunoallergic and autoimmune features are uncommon. These features are also typical of the hepatotoxicity of diclofenac which like etodolac is an acetic acid derivative. Several cases of fatal acute liver failure in patients taking etodolac have been described, some of which demonstrate a pattern of hyperacute hepatic necrosis resembling acetaminophen overdose or acute hepatic ischemia. Interestingly, etodolac causes a false positive reaction on dipstick testing for bilirubin in urine.

Likelihood score: C (probable rare cause clinically apparent liver injury).

### Mechanism of Injury

The mechanism of etodolac hepatotoxicity is not known, but likely to be due to an idiosyncratic reaction to an intermediate of its metabolism. Etodolac is extensively metabolized by the liver.

### Outcome and Management

Severity ranges from asymptomatic elevations in serum aminotransferase levels, to symptomatic hepatitis with or without jaundice. Fatal cases have been described. Patients with etodolac induced clinically apparent liver injury should avoid other acetic acid derivatives such as sulindac, diclofenac, ketorolac, tolmetin and indomethacin.

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORTS

### Case 1. Acute hepatitis attributed to etodolac.(1)

A 55 year old woman developed anorexia followed by skin rash 7 months after starting etodolac (400 mg twice daily) for osteoarthritis. She stopped the etodolac, but went on to develop dark urine and jaundice. She had no history of liver disease, alcohol abuse, risk factors for viral hepatitis or drug allergies. Her other medical conditions included hypothyroidism for which she took levothyroxine and reactive airway disease for which she had taken montelukast daily for several years. She also took multivitamins, but denied exposure to other over-the-counter or herbal products. On examination, she had an erythematous rash over the thorax, but no fever or lymphadenopathy, and no signs of chronic liver disease. Laboratory tests showed total serum bilirubin of 4.0 mg/dL, ALT 661 U/L, AST 501 U/L, alkaline phosphatase 128 U/L and albumin 4.0 g/dL. Tests for hepatitis A, B, C (including HCV RNA) and E were negative as were ANA and SMA. An abdominal ultrasound showed gallstones, but no evidence of biliary obstruction. She was monitored as an outpatient and improved rapidly. Her symptoms resolved within one month and all liver tests were normal within two months of the initial presentation (Table). She did not restart etodolac.

#### Key Points

Medication: | Etodolac
Pattern: | Hepatocellular (R=19.3)
Severity: | 2+ (jaundiced but not hospitalized)
Latency: | 7 months
Recovery: | 7 weeks
Other medications: | Montelukast, levothyroxine, multivitamins

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
7 months | 14 days | 661 | 128 | 4.0 | Ultrasound normal
| 21 days | 327 | 102 | 2.7
| 30 days | 114 | 87 | 1.6 | Asymptomatic
8 months | 37 days | 56 | 66 | 1.3
| 44 days | 35 | 58 | 1.4
| 51 days | 27 | 58 | 0.8
10 months | 3 months | 16 | 54 | 0.8
18 months | 12 months | 22 | 46 | 0.8
Normal Values | | <65 | <136 | <1.2

#### Comment

This woman developed a mild, but clinically apparent acute hepatitis 7 months after starting daily etodolac therapy for osteoarthritis. Immunoallergic features were present (rash), but not prominent (eosinophil counts were not available). Other causes of acute hepatitis were excluded. Montelukast can cause acute liver injury, but she had been on this medication for several years. Rechallenge with motelukast with careful monitoring would have been appropriate.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Etodolac – Generic, Lodine®

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=etodolac)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Etodolac | 41340-25-4 | C17-H21-N-O3

## CITED REFERENCE

1 Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9.26601797

## ANNOTATED BIBLIOGRAPHY

References updated: 20 July 2025

Abbreviations used: NSAID, nonsteroidal anti-inflammatory drug; COX-1 and -2, cyclo-oxygenase 1 and 2; PIE, pulmonary infiltrates with eosinophilia; DRESS, drug reaction with eosinophilia and systemic symptoms; VBDS, vanishing bile duct syndrome.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-553. (Expert review of hepatotoxicity published in 1999; mentions that etodolac is associated with a low rate of serum aminotransferase elevations and has been implicated in a few cases of acute liver injury with jaunidce).
Lewis JH, Stine JG. Nonsteroidal anti-inflammatory drugs and leukotriene receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 369-401. (Review of hepatotoxicity of NSAIDs) mentions that ALT elevations occur in <1% of patients on etodolac and discusses a case report of acute liver failure [Mabee et al 1995]).
Grossner T, Smyth EM, Fitzgerald GA. Pharmacotherapy of inflammation, fever, pain, and gout. In, Brunton LL, Hilal-Dandan R, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 13th ed. New York: McGraw-Hill, 2018. pp. 685-709. (Textbook of pharmacology and therapeutics).
Boldy DA, Hale KA, Vale JA. Etodolac overdose. Hum Toxicol 1988; 7: 203-4. (53 year old woman took an overdose of etodolac [44 tablets] and underwent gastric lavage 2 hours later, remaining asymptomatic and with no abnormalities in "biochemical profile", testing showing therapeutic plasma levels, suggesting that gastric lavage had been effective). 2967796
Karbowski A. A global safety evaluation of etodolac. Clin Rheumatol 1989; 8 (Suppl 1): 73-9. (Review of the literature and data on file with sponsor on safety of etodolac: liver test abnormalities occurred in 1-2% of treated patients, but none withdrew because of laboratory abnormalities. In clinical practice studies on 543 patients there were no reports of hepatitis or liver function test abnormalities). 2525986
Zimmerman HJ. Update of hepatotoxicity due to classes of drugs in common clinical use: non-steroid drugs, anti-inflammatory drugs, antibiotics, antihypertensives, and cardiac and psychotropic agents. Semin Liver Dis 1990; 10: 322-8. (Extensive review article on liver injury due to NSAIDs; mentions that etodolac has “led to little or no hepatic injury”). 2281340
Schattenkirchner M. An update safety profile of etodolac in several thousand patients. Eur J Rheumatol Inflamm 1990; 10: 56-65. (In clinical trials, 31 of 3,302 [0.9%] patients on etodolac stopped treatment because of elevated liver enzymes [ALT, AST or Alk P] or bilirubin, compared to 0.4% of placebo- and 4% of aspirin-recipients). 2146132
Serni U. Global safety of etodolac: reports from worldwide postmarketing surveillance studies. Rheumatol Int 1990; 10 (Suppl): 23-7. (Summary of 4 postmarketing studies of safety of etodolac from Europe in over 8000 patients; in a French study of 1269 patients, 2 cases of hepatoxicity were reported, one with jaundice only and one with cholestatic hepatitis). 2150568
Benhamou CL. Large-scale open trials with etodolac (Lodine) in France: an assessment of safety. Rheumatol Int 1990; 10 Suppl: 29-34. (Analysis of safety in 4997 patients in randomized clinical trials of 30 day course of etodolac in rheumatoid arthritis and osteoarthritis, found one patient with marked ALT elevations at 15 days and one case of cholestatic hepatitis, both resolving; in 51,355 patients in postmarketing surveillance, only 2 hepatic adverse reactions were reported, but no details given). 2150569
Schattenkirchner M. Double-blind comparison of etodolac and piroxicam in patients with rheumatoid arthritis. Curr Med Res Opin 1991; 12: 497-50. (60 patients given etodolac [200 mg twice daily] or piroxicam [20 mg once daily] for 12 weeks with blood chemistries done at start and stop of therapy; “There were no clinically significant changes in laboratory parameters in either treatment group”). 1837260
Etodolac. Medical Letter 1991; 33: 79-80. (Short review of etodolac indicating that it is as effective as other NSAIDs but unlikely to be more safe; also mentions that drug associated hepatic dysfunction has been reported). 1830919
Latrive JP, Combaux D, Crepin P, Brbara JC. Acute hepatitis associated with etodolac therapy. Therapie 1992; 47: 82. (32 year old woman with anklyosing spondylitis developed jaundice 5 days after starting etodolac [bilirubin 6.3 mg/dL, ALT 8 times and Alk P 2.7 times ULN] with complete resolution in 2 months). 1387992
Schattenkirchner M. The safety profile of sustained-release etodolac. Rheumatol Int 1993; 13 (Suppl 2): S31-5. PubMed Citation (Among 539 patients with osteoarthritis or rheumatoid arthritis given once daily sustained release etodolac in 4 open-label studies for up to 1 year; “most laboratory abnormalities were transient and did not affect the patient’s health status.” 6 patients withdrew because of laboratory abnormalities, all of which resolved except for one patient with preexisting liver test abnormalities; no mention of hepatitis or jaundice). 8210923
García Rodríguez LA, Williams R, Derby LE, Dean AD, Jick H. Acute liver injury associated with nonsteroidal anti-inflammatory drugs and the role of risk factors. Arch Intern Med 1994; 154: 311-6. PMID: (Population based study of 625,307 UK subjects who received at least one prescription for one of 12 NSAIDs [etodolac not mentioned], of whom 35 subsequently had liver injury: 12 only liver tests abnormal, 23 acute symptomatic injury for and overall incidence of 1 per 100,000 prescriptions or 4 per 100,000 users). 8297198
Schnitzer TJ, Ballard IM, Constantine G, McDonald P. Double-blind, placebo-controlled comparison of the safety and efficacy of orally administered etodolac and nabumetone in patients with active osteoarthritis of the knee. Clin Therapeut 1995; 17: 602-12. (In a prospective controlled trial, mild ALT elevations occurred in 3 of 89 nabumetone-, none of 90 etodac-, and 2 of 90 placebo treated patients; no mention of outcome or symptoms). 8565024
Mabee CL, Mabee SW, Baker PB, Kirkpatrick RB, Levine EJ. Fulminant hepatic failure associated with etodolac use. Am J Gastroenterol 1995; 90: 660-2. (67 year old woman developed an acute hepatitis 4 months after starting etodolac for osteoarthritis [bilirubin 11.8 mg/dL, ALT 1554 U/L, Alk P 193 U/L, protime 21.4 sec], progressing to hepatic failure and death within 3 weeks of onset). 7717333
Neustadt DH. Double blind evaluation of the long-term effects of etodolac versus ibuprofen in patients with rheumatoid arthritis. J Rheumatol Suppl 1997; 47: 17-22. (Randomized trial of 2 doses of etodolac vs ibuprofen in 1446 patients with rheumatoid arthritis treated for up to 3 years; similar efficacy; “Changes in hepatic and renal function were similar across treatment groups” and “rates… were low”, but higher dose of etodolac had higher rate of Alk P elevations; all resolved with stopping). 9035016
Cunha PD, Lord RS, Johnson ST, Wilker PR, Aster RH, Bougie DW. Immune hemolytic anemia caused by sensitivity to a metabolite of etodolac, a nonsteroidal anti-inflammatory drug. Transfusion 2000; 40: 663-8. (41 year old woman developed jaundice after intermittent use of etodolac [total bilirubin 17.6 mg/dL, direct 6.8 mg/dL, AST 284 U/L, Alk P 125 U/L, protime 19.8 sec] with hemolytic anemia [hematocrit 18%, positive direct Coombs test], resolving within 2 months but with recurrence of hemolysis on restarting etodolac). 10864985
Rubenstein JH, Laine L. Systematic review: the hepatotoxicity of non-steroidal anti-inflammatory drugs. Aliment Pharmacol Ther 2004; 20: 373-80. (NSAIDs are the most commonly used drugs in the U.S. and account for a large proportion of cases of hepatic injury, but the frequency is quite rare. Among 7 population based studies, hospitalization occurred in 22.4 per 100,000 patient-years [rate ratio 1.5], and ~1 death per 100,000 patient-years was due to liver injury; rate of injury did not increase with age or vary by gender; in case controlled studies, higher odds ratios were found with sulindac, indomethacin, piroxicam and diclofenac; analysis dealt largely with commonly used NSAIDs and did not mention etodolac). 15298630
Rostom A, Goldkind L, Laine L. Nonsteroidal anti-inflammatory drugs and hepatic toxicity: a systematic review of randomized controlled trials in arthritis patients. Clin Gastroenterol Hepatol 2005; 3: 489-98. (Review of randomized clinical trials of NSAIDS for frequency of adverse events; ALT above 3 times ULN in 0.43% of ibuprofen, 0.43% naproxen, 0.42% celecoxib, 1.8% rofecoxib, 3.55% diclofenac and 0.29% of placebo recipients, rare liver-related serious adverse effects or deaths with any; dealt largely with commonly used NSAIDs and did not mention etodolac). 15880319
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Survey of all cases of drug induced liver injury with fatal outcome from Swedish Adverse Drug Reporting system from 1966-2002: among 103 cases, none were attributed to etodolac). 16165719
Griffin A. Case of the month. Chronic hepatitis. JAAPA 2006; 19: 70. (54 year old man taking etodolac for low back pain was found to have 3+ bilirubin in urine by dipstick, but serum ALT, AST and bilirubin were normal; the reaction because negative 10 days after stopping and was positive again 2 weeks after restarting, due to false-positive reaction of the diazo reagent). 17124794
Lapeyre-Mestre M, de Castro AM, Bareille MP, Del Pozo JG, Requejo AA, Arias LM, et al. Non-steroidal anti-inflammatory drug-related hepatic damage in France and Spain: analysis from national spontaneous reporting systems. Fundam Clin Pharmacol 2006; 20: 391-5. (Analysis of reports of liver injury from NSAIDs from France and Spain from 1982-2001; etodolac is not listed in tables of adverse event reports from NSAIDs). 16867024
Arellano FM, Yood MU, Wentworth CE, Oliveria SA, Rivero E, Verma A, et al. Use of cyclo-oxygenase 2 inhibitors(COX-2) and prescription non-steroidal anti-inflammatory drugs (NSAIDS) in UK and USA populations Implications for COX-2 cardiovascular profile. Pharmacoepidemiol Drug Saf 2006; 15 :861-72. (Survey of NSAID use in UK and USA indicates ibuprofen, naproxen and diclofenac are the most commonly used; etodolac was not among the top 10 agents used). 17086563
Jensen M, Engert A, Weissinger F, Knauf W, Kimby E, Poynton C, et al. Phase I study of a novel pro-apoptotic drug R-etodolac in patients with B-cell chronic lymphocytic leukemia. Invest New Drugs 2008; 26: 139-49. (Use of high doses of a R-enanomer of etodolac [1.2 to 4.8 g/day] was associated with decrease in lymphocyte counts in patients with chronic lymphocytic leukemia; the activity was separate from Cox inhibition and not shared by other NSAIDs; in this phase I trial, ALT elevations occurred in 11 of 45 patients [26%], were unrelated to dose, and led to drug withdrawals in 3 [7%]; no mention of hepatitis). 18094935
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, NSAIDs were implicated as a sole agent in 8 cases [4 diclofenac, 2 celecoxib, 1 meloxicam and 1 oxaprozin] and as one of several agents in 3 cases [1 diclofenac, 1 celecoxib, 1 ibuprofen]; no cases were attributed to etodolac). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 7 were due to NSAIDs, including 4 attributed to bromfenac, 2 to diclofenac and 1 to etodolac). 20949552
Bessone F. Non-steroidal anti-inflammatory drugs: What is the actual risk of liver damage? World J Gastroenterol 2010; 16: 5651-61. (Review of estimated frequency of drug induced liver injury due to NSAIDs from large published epidemiological studies; mentions that etodolac has been associated with various hepatic reactions). 21128314
Hunter LJ, Wood DM, Dargan PI. The patterns of toxicity and management of acute nonsteroidal anti-inflammatory drug (NSAID) overdose. Open Access Emerg Med. 2011 Jul 6;3:39-48.. (Review of the clinical features of severe outcomes of overdose with NSAIDs mentions that acetaminophen is the most frequent cause of overdose with analgesics followed by ibuprofen and then naproxen, but does not mention etodolac). 27147851
Vogts N, Young S. Pulmonary infiltrates with eosinophilia syndrome in ibuprofen overdose. N Z Med J. 2012;125:74-5.. (45 year old woman developed 2 days of drowsiness after an overdose of “Neurofen Plus” tablets [codeine and ibuprofen] with metabolic acidosis, renal dysfunction, and bilateral patchy pulmonary infiltrates with eosinophilia [600/uL] which improved within 5 days and chest X-ray was normal after 4 weeks, an example of PIE syndrome which has been reported with multiple NSAIDs including diclofenac, naproxen, meloxicam, fenbufen, nimesulide and diflunisal, but does not mention etodolac). 22932657
Mehta P, Lukacs M, Abraham SM. Normal in the blood, abnormal in the urine. QJM 2012; 105: 1001-2. (67 year old woman with rheumatoid arthritis on etodolac had persistent positive urine dipstick reaction for bilirubin despite normal serum bilirubin and liver tests; false positive reaction was due to etodolac). 21880696
Sampaziotis F, Brais RJ, Griffiths WJ. A case of acute liver failure due to etodolac. Br J Clin Pharmacol 2013; 75: 1156-7. (73 year old woman developed jaundice 6 months after starting etodolac [bilirubin 30.7 mg/dL, ALT 1400 U/L, Alk P 274 U/L, protime 16.7 seconds], developing hepatic encephalopathy, but then recoverying spontaneously within 3 months of stopping). 22943552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25 (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 6 attributed to diclofenac [ranking 2nd], but none due to etodolac). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common class of implicated agents being NSAIDS [n=62, 32%], but specific agents were nimesulide [n=53], piroxicam [5], diclofenac [2], gold salts [1], and naproxen [1]; etodolac was not listed]). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 28 were attributed to NSAIDs, including 2 to etodolac [Schmeltzer 2016]). 25754159
Ishiguro N, Hanaoka A, Okada T, Ito M. Efficacy and safety of celecoxib compared with placebo and etodolac for acute postoperative pain: a multicenter, double-blind, randomized, parallel-group, controlled trial. Nagoya J Med Sci. 2015;77(1-2):81-93.. (Among 616 patients with moderate to severe post-operative pain treated with celecoxib (initially 400 mg then 200 mg], etodolac [200 mg], or placebo twice daily for at least 2 days, pain control was achieved in 76% vs 68% vs 64%, adverse event rates were similar in the 3 groups, mild ALT elevations occurring in 0.8% vs 1.2% vs none, and there were no serious adverse events) 25797973
Schmeltzer PA, Kosinski AS, Kleiner DE, Hoofnagle JH, Stolz A, Fontana RJ, Russo MW; Drug-Induced Liver Injury Network (DILIN). Liver injury from nonsteroidal anti-inflammatory drugs in the United States. Liver Int 2016; 36: 603-9. (Among 1221 cases of drug induced liver injury enrolled in a prospective, US database between 2004 and 2014, 30 cases [2.5%] were attributed to NSAIDs, including 2 due to etodolac [Case 1], both of which presented with jaundice 5 and 7 months after starting [bilirubin 3.8 and 4.0 mg/dL, ALT 322 and 661 U/L, Alk P 128 and 341 U/L, INR 1.0 and 1.0], both recovering rapidly upon stopping without residual injury). 26601797
Taneja S, Kumar P, Rathi S, Duseja A, Singh V, Dhiman RK, Chawla YK. Acute liver failure due to etodolac, a selective cycloxygenase- 2 (COX -2) inhibitor non-steroidal anti-inflammatory drug established by RUCAM-based causality assessment. Ann Hepatol 2017; 16: 818-21. (Two women, ages 27 and 80 years, developed nausea and vomiting within 48 hours of starting a fixed combination of etodolac [400 mg] and acetminophen [500 mg] twice daily followed rapidly by jaundice and confusion [bilirubin 4.3 and 4.4 mg/dL, ALT 6060 and 6896 U/L, Alk P 229 and 78 U/L , INR 6.7 and 4.0] with hyperammonemia and lactic acidosis, one patient dying within 2 days and the other recovering rapidly, a pattern indicative of acute hepatic necrosis). 28809737
Tujios SR, Lee WM. Acute liver failure induced by idiosyncratic reaction to drugs: challenges in diagnosis and therapy. Liver Int 2018; 38: 6-14. (Review of acute liver failure and the contribution of drug induced liver injury, of which 5% were due to NSAIDs, most commonly diclofenac and etodolac). 28771932
Meunier L, Larrey D. Recent advances in hepatotoxicity of non-steroidal anti-inflammatory drugs. Ann Hepatol 2018; 17: 187-91. (Review of the hepatotoxicity of NSAIDS mentions the most commonly implicated are diclofenac, nimesulide, sulindac, ibuprofen, piroxicam, naproxen and aspirin). 29469052
Teschke R. Top-ranking drugs out of 3312 drug-induced liver injury cases evaluated by the Roussel Uclaf Causality Assessment Method. Expert Opin Drug Metab Toxicol. 2018;14:1169-1187.. (In a review of 3312 published cases of drug-induced liver injury using RUCAM to define causality, diclofenac ranked 5^th^ and ibuprofen ranked 8^th^ in frequency, whereas other NSAIDs, including etodolac, are not mentioned). 30354694
Gulmez SE, Unal US, Lassalle R, Chartier A, Grolleau A, Moore N. Risk of hospital admission for liver injury in users of NSAIDs and nonoverdose paracetamol: Preliminary results from the EPIHAM study. Pharmacoepidemiol Drug Saf. 2018;27:1174-1181. PMID:. (In a case-population controlled study of a French hospitalization claims database, 63 cases of acute liver injury were identified, 13 of which had been exposed recently to an NSAID including 6 to diclofenac, 4 to ibuprofen, 3 to ketoprofen, but none to etodolac). 30112779
Nonopioid drugs for pain. Med Lett Drugs Ther. 2022;64(1645):33-40.. (Concise review of the nonopioid drugs for pain mentions that NSAIDs are considered to be more effective than acetaminophen for mild to moderate pain and that they can cause small increases in serum aminotransferase levels but that serious hepatotoxicity is rare, occurring most frequently with diclofenac, while cholestatic hepatitis has been reported with use of celecoxib). 35231019
Ma J, Björnsson ES, Chalasani N. The safe use of analgesics in patients with cirrhosis: a narrative review. Am J Med. 2024;137:99-106.. (Review of the safety of analgesic use in patients with cirrhosis, mentions that acetaminophen is considered the safest nonopioid but that the dose should be limited to 2 g daily with prolonged therapy in persons with cirrhosis and that NSAIDs are generally thought to be contraindicated in patients with cirrhosis, but celecoxib can be used at typical doses with Child’s class A cirrhosis (compensated), but should be reduced by 50% in patients with Child’s B and avoided in those with Child’s C cirrhosis). 37918778
Bonkovsky HL, Ghabril M, Nicoletti P, Dellinger A, Fontana RJ, Barnhart H, Gu J, et al; US DILIN Investigators. Drug-induced liver injury (DILI) ascribed to non-steroidal anti-inflammatory drugs (NSAIDs) in the USA-Update with genetic correlations. Liver Int. 2024;44:1409-1421.. (Among 55 cases of drug induced liver injury attributed to NSAIDs enrolled in a U.S. database between 2004 and 2022, 29 were attributed to diclofenac, 7 to celecoxib, 5 to ibuprofen, 4 to both etodolac and meloxicam, 2 to oxaprozin, and only 1 to both naproxen and sulindac). 38451034
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be attributed to prescribed medications, at calculated rates for NSAIDs of 1:7,700 for sulindac, 1:8,300 for indomethacin, 1:9,100 for naproxen, 1:11,000 for ibuprofen, 1:12,500 for diclofenac, and 1:14,300 for celecoxib; etodolac is not mentioned). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of idiosyncratic drug-induced liver injury enrolled in a prospective Latin American database over a 10 year period, 49 were attributed to NSAIDs, including 19 [4.1%] due to diclofenac, 14 [3.0%] to nimeslide, and 11 [2.4%] to ibuprofen; the implicated agents of the remaining 5 NSAID cases were not mentioned). 38992407
Sánchez-Luquez K, Reis Silveira AM, Sánchez-Vinces S, Rosini Silva AA, Barreto J, Lemos de Brito RBS, Garcia CM, et al. Etodolac single dose metabolic profile elucidation: pharmacokinetics and adverse events in healthy volunteers. Pharmaceuticals (Basel). 2025;18:82.. (Single dose pharmacokinetic studies of etodolac [500 mg] in 37 healthy volunteers demonstrated rapid absorption and t1/2 of 8 hours while metabolomic analyses demonstrated the expected effects on arachodoic acid metabolites but also alteration in pathways of cholesterol, bile salt and riboflavin biosynthesis and retinoic acid signaling). 39861145

## OTHER REFERENCE LINKS

1. Recent References on Etodolac: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(etodolac/AE+NOT+clavulanic+acid)+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Etodolac: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=etodolac)